# Abrocitinib

## OVERVIEW

### Introduction

Abrocitinib is an orally available, small molecule inhibitor of Janus kinase 1 (JAK1) that is used to treat moderate-to-severe atopic dermatitis. Abrocitinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy, but has not been linked to cases of clinically apparent acute liver injury.

### Background

Abrocitinib (ab” roe sye' ti nib) is an orally available, small molecule, specific inhibitor of Janus-associated kinase 1 (JAK1) that is used to treat refractory, moderate-to-severe atopic dermatitis. The JAK proteins are intracellular tyrosine kinases that provide critical steps in pathways of immune activation as well as in hematopoiesis. There are four mammalian JAK proteins (JAK1-3 and TY2K), all of which are involved in cell signaling in response to inflammatory cytokines such as interleukins and interferons. JAK1 is specifically involved in modulating the effects of IL-4, IL-23, IL-22 and IL-31, which play roles in the pathogenesis of several inflammatory conditions including atopic dermatitis. In several large, placebo controlled trials, abrocitinib was found to improve symptoms in adults with atopic dermatitis who had failed to respond to topical and other systemic therapies. Abrocitinib was approved in the United States in 2022 as therapy for adults with refractory, moderate-to-severe atopic dermatitis. It is currently being evaluated for efficacy and safety in adolescents. Abrocitinib is available in tablets of 50, 100 and 200 mg under the brand name Cibinqo. The recommended starting dose is 100 mg once daily which can be increased or decreased based upon efficacy and tolerance. Common side effects of abrocitinib are nausea, headache, dizziness, thrombocytopenia and herpes simplex infections. Rare but potentially severe adverse events may include severe bacterial, fungal, viral or opportunistic infections, reactivation of latent tuberculosis or herpes zoster, and severe thrombocytopenia. Recently, all of the product labels of small molecule JAK inhibitors including abrocitinib have been given a boxed warning because of increased rates of all-cause mortality including cardiovascular deaths, and increased risk for malignancies including lymphomas and lung cancer, venous and arterial thromboses, and major cardiovascular events (MACE).

### Hepatotoxicity

In the large registration clinical trials, serum aminotransferase elevations occurred rarely and were not attributed to abrocitinib. These elevations were typically mild and transient, and values above 3 times the upper limit of normal (ULN) occurred in less than 1% of patients on abrocitinib. In prelicensure studies, there were no instances of clinically apparent liver injury attributed to abrocitinib. Since approval of abrocitinib, there have been no published reports of hepatotoxicity associated with its use, but clinical experience with its use has been limited.

While other Janus kinase inhibitors such as ruxolitinib have been associated with episodes of reactivation of hepatitis B, spontaneous reports of clinically apparent reactivation of hepatitis during abrocitinib therapy have not been reported.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations during abrocitinib therapy are not known. Abrocitinib is metabolized in the liver largely by CYP 2C9 and 3A4 pathways and may be susceptible to drug-drug interactions with agents that inhibit or induce these specific hepatic microsomal enzymes.

### Outcome and Management

There is no recommendation for monitoring of routine liver tests during abrocitinib therapy. Because abrocitinib may cause reactivation of hepatitis B, patients starting long term therapy should be screened for HBsAg and anti-HBc. Patients with preexisting HBsAg in serum should undergo evaluation and prophylaxis against reactivation of HBV using potent oral antiviral agents, such as tenofovir or entecavir. Those with anti-HBc without HBsAg or HBV DNA should be monitored for evidence of infection and treated if there is de novo appearance of HBsAg or HBV DNA.

Drug Class: Protein Kinase Inhibitors

Other Drugs in the Subclass, Janus Kinase Inhibitors: Baricitinib, Fedratinib[underlined: ,] Ruxolitinib, Tofacitinib, Upadacitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Abrocitinib – Cibinqo®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Abrocitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Abrocitinib | 1622902-68-4 | C14-H21-N5-O2-S
Tofacitinib | 477600-75-2 | C16-H20-N6-O

## ANNOTATED BIBLIOGRAPHY

References updated: 13 June 2022

Abbreviations: JAK, Janus kinase.
Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as abrocitinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not abrocitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics; abrocitinib is not discussed specifically).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/213871Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website with product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy of abrocitinib mentions that there were no meaningful change over time in measures of central tendency for ALT or AST or increased frequency of ALT or AST values above 3 or 5 times ULN).
Ghoreschi K, Laurence A, O'Shea JJ. (2009). Janus kinases in immune cell signaling. Immunol Rev. (Review of the Janus kinases structure and role in immune reactions and hematopoiesis as well as the promise of JAK inhibitors in treating autoimmune diseases).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; abrocitinib is not discussed).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; abrocitinib is not mentioned).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases were attributed to drugs for rheumatoid arthritis: all 5 due to leflunomide and none to abrocitinib).
Gooderham MJ, Forman SB, Bissonnette R, Beebe JS, Zhang W, Banfield C, Zhu L, et al. (2019). Efficacy and safety of oral Janus Kinase 1 inhibitor abrocitinib for patients with atopic dermatitis: a phase 2 randomized clinical trial. JAMA Dermatol. (Among 267 adults with atopic dermatitis treated with abrocitinib [10, 30, 100 or 200 mg] or placebo once daily for 12 weeks, global assessment improvements occurred in 11%, 10%, 30% and 44% vs 6% with placebo, while adverse events were most common with higher doses and included headache, nausea, diarrhea and transient thrombocytopenia; no mention of ALT elevations or hepatotoxicity).
Simpson EL, Sinclair R, Forman S, Wollenberg A, Aschoff R, Cork M, Bieber T, et al. (2020). Efficacy and safety of abrocitinib in adults and adolescents with moderate-to-severe atopic dermatitis (JADE MONO-1): a multicentre, double-blind, randomised, placebo-controlled, phase 3 trial. Lancet. (Among 387 patients with moderate-to-severe atopic dermatitis treated with abrocitinib [100 or 200 mg] or placebo once daily for 12 weeks, global assessment response rates were higher with abrocitinib [24% and 44% vs 8%] as were adverse events rates [69% and 78% vs 57%], but not severe adverse events [3% and 3% vs 4%]; symptoms more frequent with abrocitinib were nausea and headache, while herpes simplex and zoster and ALT elevations arose in 1% or less and there were no severe liver related events).
Silverberg JI, Simpson EL, Thyssen JP, Gooderham M, Chan G, Feeney C, Biswas P, et al. (2020). Efficacy and safety of abrocitinib in patients with moderate-to-severe atopic dermatitis: a randomized clinical trial. JAMA Dermatol. (Among 391 adults and adolescents with moderate-to-severe atopic dermatitis treated with abrocitinib [100 or 200 mg] or placebo once daily for 12 weeks, global symptom assessment scores were improved in 28% and 38% vs 9%, while adverse event rates were 66% vs 66% vs 54%, and serious event rates were 1.3%, 3.2% and 1.3%; no mention of ALT elevations or hepatotoxicity).
(2020). Drugs for atopic dermatitis. Med Lett Drugs Ther. (Concise review of the approved drugs for therapy of atopic dermatitis, including their mechanism of action, clinical efficacy, safety and relative costs: mentions that JAK inhibitors such as abrocitinib have used off label and experimentally for atopic dermatitis; no mention of adverse events or ALT elevations).
Satarker S, Tom AA, Shaji RA, Alosious A, Luvis M, Nampoothiri M. (2021). JAK-STAT pathway inhibition and their implications in COVID-19 therapy. Postgrad Med. (Review of the mechanism of action and pleomorphic activities of Janus kinase inhibitors and their possible role in treating severe COVID-19 infection, which is often accompanied by high levels of proinflammatory cytokines [cytokine storm] with listing of ongoing trials including several of tofacitinib).
Wong HS, Guo CL, Lin GH, Lee KY, Okada Y, Chang WC. (2021). Transcriptome network analyses in human coronavirus infections suggest a rational use of immunomodulatory drugs for COVID-19 therapy. Genomics. (Analysis of the temporal pattern of upregulation of genes in cells infected with SARS-CoV-2 suggest that medications most likely to affect these changes include among others dexamethasone, baricitinib, tofacitinib, sarilumab, ritonavir, naproxen, avelumab, durvalumab and atezolizumab).
Bieber T, Simpson EL, Silverberg JI, Thaçi D, Paul C, Pink AE, Kataoka Y, et al., JADE COMPARE Investigators. (2021). Abrocitinib versus placebo or dupilumab for atopic dermatitis. N Engl J Med. (Among 838 patients with atopic dermatitis with inadequate response to topical agents, treated with abrocitinib [100 or 200 mg daily], dupilumab [300 mg every 2 weeks] or placebo, the global assessment response was 37% and 48% vs 37% and 14%, while symptoms of nausea and acne were more frequent with abrocitinib and there were 6 cases of herpes zoster; there were no elevations in serum ALT or AST).
Deeks ED, Duggan S. (2021). Abrocitinib: first approval. Drugs. (Concise review of the chemical structure, mechanism of action, history of development, clinical efficacy and tolerance of abrocitinib, a small molecule inhibitor of JAK1 which impacts many downstream antiinflammatory cytokines and has been shown to improve symptoms in patients with refractory atopic dermatitis).
Raghuvanshi R, Bharate SB. (2022). Recent developments in the use of kinase inhibitors for management of viral infections. J Med Chem. (Review of the kinase inhibitors approved for use in the US, their mechanisms of action and possible role in inhibiting viral replication).
Blauvelt A, Silverberg JI, Lynde CW, Bieber T, Eisman S, Zdybski J, Gubelin W, et al. (2022). Abrocitinib induction, randomized withdrawal, and retreatment in patients with moderate-to-severe atopic dermatitis: Results from the JAK1 Atopic Dermatitis Efficacy and Safety (JADE) REGIMEN phase 3 trial. J Am Acad Dermatol. (Among 798 patients with moderate-to-severe atopic dermatitis who responded to a 12 week course of abrocitinib [200 mg daily] and were then randomized to continue on 100 or 200 mg vs switching to placebo [withdrawal] for 40 weeks, relapse occurred in 43% and 19% vs 81%, and adverse events were greatest with the high doses of abrocitinib; no mention of ALT elevations or hepatoxicity).
Shawky AM, Almalki FA, Abdalla AN, Abdelazeem AH, Gouda AM. (2022). A comprehensive overview of globally approved JAK inhibitors. Pharmaceutics. (Review of the JAK-STAT pathways and currently approved JAK inhibitors; JAK proteins are cytoplasmic, non-receptor tyrosine kinases involved in transduction of cytokine signals that pair when binding to transmembrane cytokine receptors and, once activated, phosphorylate STAT causing their dimerization and transfer to the nucleus where they activate cytokine induced genes).
Wood H, Chandler A, Nezamololama N, Papp K, Gooderham MJ. (2022). Safety of Janus kinase (JAK) inhibitors in the short-term treatment of atopic dermatitis. Int J Dermatol. (Review of the safety of JAK inhibitors including abrocitinib, baricitinib, upadacitinib, and ruxolitinib mentions that common adverse events are headache [5-10%], nausea [2-20%], transient thrombocytopenia, herpes simplex [0-7%] and herpes zoster [0-2%]; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Abrocitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Abrocitinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Abrocitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Abrocitinib)